# Uva Ursi

## OVERVIEW

### Introduction

Uva ursi is an herbal extract derived from the leaves of the Arctostaphylos, a small evergreen shrub, which has been used in Native American traditional medicine for treatment of urinary tract symptoms and as a diuretic. Treatment with extracts of uva ursi has not been specifically linked to serum aminotransferase elevations or to instances of clinically apparent acute liver injury.

### Background

Uva ursi is an herbal product derived from the fresh or dried leaves of the plant Arctostaphylos uva-ursi or bearberry, named for the grape-like clusters of orange berries that are commonly eaten by bears. Both Arctostaphylos and uva-ursi mean “grape of the bears”, the former in Greek and the latter in Latin. Uva ursi leaves contain several phytochemicals, including ursolic acid, tannic acid, gallic acid, oils, resins, hydroquinone glycosides (mainly “arbutin”), and flavonoids. The active component of uva ursi is suspected to be hydroquinone, and particularly arbutin and methyl arbutin which may have antiinflammatory and antiseptic activities that are excreted in the urine. Uva ursi has been used to treat dysuria, cystitis, urethritis, and kidney and bladder stones. It has also been recommended for inducing diuresis and to treat constipation. In addition, the leaves of Arctostaphylos have been dried and smoked as tobacco, while leaves and berries have also been used as food. While uva ursi has been used extensively in traditional medicine, there is no convincing medical evidence that it is effective in treating urinary tract infections or urinary symptoms. More recently, uva ursi has been included in multiingredient dietary supplements meant for a variety of conditions such as to induce weight loss, promote wellness, prevent the effects of aging and to increase energy and stamina. Uva ursi is typically available in tablets and capsules of 150, 455 and 505 mg and is taken one to three times daily. It can also be prepared as tea from dried leaves or a powdered extract. Commercial products that contain uva ursi include SLIMQUICK Ultra and Animal Cuts. Side effects are not common but, in high doses, may include nausea, vomiting, tinnitus, shortness of breath and allergic reactions. Rare but potentially severe reactions to high doses of uva ursi may include convulsions, delirium and cardiovascular collapse.

### Hepatotoxicity

Uva ursi has not been linked to serum enzyme elevations during therapy although there have been few prospective studies of its adverse effects on laboratory test results. There have been no convincing published instances of clinically apparent liver injury attributed to uva ursi. The frequency of hypersensitivity reactions to uva ursi is not known.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Bearberry, Bear grape, Mountain cranberry, Redberry, Kinnikinnik, Arctostaphylos

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Uva Ursi – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Arctostaphylos Uva-ursi Extract | 84776-10-3 | Unspecified

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but uva ursi is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention uva ursi).
Uva-Ursi. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 868-71. (Compilation of short monographs on herbal medications and dietary supplements).
Larsson B, Jonasson A, Fianu S. (1993). Prophylactic effect of UVA-E in women with recurrent cystitis: a preliminary report. Curr Ther Res. (Among 57 women with frequent episodes of cystitis treated with UVA-E [unknown dose] or placebo for one month, episodes of cystitis occurred in the next year in none of 30 treated with uva ursi but in 5 of 27 receiving placebo).
Yarnell E. (2002). Botanical medicines for the urinary tract. World J Urol. (Review of botanical agents that are purported to have effects in urologic conditions including uva ursi which is approved for treatment of lower urinary tract infection by the German Commission E; the active component is believed to be arbutoside which is hydrolyzed in the stomach releasing hydroquinone that is absorbed and metabolized to the glucuronide in the liver, which is then rapidly excreted in the urine where free hydroquinone is released [if urine is alkaline] and acts locally as an antiseptic; an issue is that hydroquinone is potentially carcinogenic so that uva ursi is recommended in short courses only and not to be taken chronically).
Schindler G, Patzak U, Brinkhaus B, von Niecieck A, Wittig J, Krähmer N, Glöckl I, et al. (2002). Urinary excretion and metabolism of arbutin after oral administration of Arctostaphylos uvae ursi extract as film-coated tablets and aqueous solution in healthy humans. J Clin Pharmacol. (In 16 healthy volunteers given arbutin either as tea made from uva ursi leaves or as an extract prepared as tablets, hydroquinone glucuronide and sulfate were rapidly detected in urine with lesser amounts of free hydroquinone in all subjects regardless of ingested form of uva ursi).
Wang L, Del Priore LV. (2004). Bull's-eye maculopathy secondary to herbal toxicity from uva ursi. Am J Ophthalmol. (57 year old woman who ingested uva ursi tea preparations several times daily for 3 years developed “bull’s eye” maculopathy which is typical of hydroxychloroquine macular injury, suggesting that hydroquinone from uva ursi which inhibits tyrosine kinase and melanin synthesis can cause macular injury as well).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to uva ursi).
Quintus J, Kovar KA, Link P, Hamacher H. (2005). Urinary excretion of arbutin metabolites after oral administration of bearberry leaf extracts. Planta Med. (Hydroquinone glucuronide and sulfate were detected in urine within 2-6 hours of ingestion of a single 150 mL preparation of tea using bearberry leaves).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to uva ursi).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling and frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of uva ursi).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to uva ursi).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but uva ursi was not listed or mentioned).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to uva ursi).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and none were attributed to uva ursi, although it was a component of several implicated multiingredient products [Navarro et al Hepatology 2014]).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not mention or list uva ursi).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention or list uva ursi).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically listing uva ursi as a component).
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. (2017). Liver injury from herbal and dietary supplements. Hepatology. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases but does not mention uva ursi as a component).
Moore M, Trill J, Simpson C, Webley F, Radford M, Stanton L, Maishman T, et al. (2019). Uva-ursi extract and ibuprofen as alternative treatments for uncomplicated urinary tract infection in women (ATAFUTI): a factorial randomized trial. Clin Microbiol Infect. (Among 382 women with urinary tract symptoms suggestive of infection treated with ibuprofen vs uva ursi vs both vs placebo for 3-5 days before recommending antibiotics, urinary symptoms were not different after 2-4 days in the four groups and subsequent use of antibiotics was unaffected by uva ursi, although recommendations to delay treatment resulted in a decrease in antibiotic use).
Datta R, Juthani-Mehta M. (2019). Antibiotic-sparing agents for uncomplicated cystitis: uva-ursi and ibuprofen not ready for primetime. Clin Microbiol Infect. (Editorial in response to Moore et al [2019] mentioning that uva ursi had no effect on urinary symptoms, but that delaying start of antibiotics for a few days by recommending ibuprofen to see if symptoms improve on their own decreases antibiotic use without increasing rates of serious complications).

## OTHER REFERENCE LINKS

1 Recent References on Uva Ursi: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Uva%20ursi+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Uva Ursi: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Uva%20ursi)